# Minocycline

## OVERVIEW

### Introduction

Minocycline is a tetracycline antibiotic with excellent absorption and tissue penetration that is used for several bacterial infections as well as treatment of acne. Minocycline can cause both an acute hepatitis-like syndrome occurring within 1 to 3 months of starting therapy or a more insidious chronic hepatitis with autoimmune features typically after long term treatment.

### Background

Minocycline (min" oh sye' kleen) is a semisynthetic derivative of tetracycline that has excellent oral absorption and wide tissue penetration. Like other tetracyclines, minocycline is believed to act by binding to bacterial ribosomes and inhibiting protein synthesis. Minocycline has a broad spectrum of activity against both gram positive and gram negative organisms. Minocycline was approved for use in the United States in 1971 and it continues in wide use, although recently at decreasing rates. Current indications are for therapy of susceptible infections, including gonorrhea, syphilis, non-gonococcal urethritis, Chlamydial infections, cholera, leprosy, and the meningococcal carrier state. The major use of minocycline, however, is for chronic treatment of acne and suppression of the staphylococcal bacterial flora that contribute to it. Minocycline is available in multiple generic forms as capsules or tablets of 50, 75 or 100 mg. For acute infections, minocycline is recommended in doses of 100 mg every 12 hours for 5 to 15 days, often after an initial loading dose of 200 mg. For therapy of acne, doses of 50 mg once to three times daily are recommended. Minocycline is also available in extended release formulations for daily dosing and as a solution or powder for intravenous use. Commercial names of minocycline include Minocin, Dynacin, Myrac, and Apo-, Novo- and PMS-Minocycline. Common side effects include nausea, diarrhea, gastrointestinal upset, headache, dizziness, visual blurring, skin rash and hypersensitivity reactions.

### Hepatotoxicity

Minocycline therapy is associated with two forms of clinically apparent liver injury, an acute hepatitis-like syndrome that arises within 1 to 3 months of starting therapy and a chronic hepatitis-like syndrome typically with autoimmune features that occurs with long term therapy, sometimes after several years of use. There is some overlap between these two presentations of minocycline hepatotoxicity, both are associated with a hepatocellular pattern of serum enzyme elevations and both can be associated with autoantibodies and immunological features.

Minocycline has been linked to cases of an acute hepatitis with jaundice that typically arises within a few weeks or months of starting therapy. The enzyme elevations are typically hepatocellular and resemble acute viral hepatitis. Immunoallergic features are common and may be prominent with fever, rash and eosinophilia and some cases with facial edema, lymphadenopathy and lymphocytosis that may resemble acute mononucleosis. The liver injury is usually self limited with complete resolution within 1 to 2 months of stopping. Some patients have autoimmune markers and these also improve upon stopping minocycline.

Minocycline has also been linked to cases of chronic hepatitis with or without jaundice that typically arise during long term therapy, sometimes after years of use. The most common presentation is with an autoimmune hepatitis-like syndrome that can be severe and even fatal, particularly if minocycline is not stopped promptly. Patients can present acutely with jaundice and fatigue or chronically with insidious onset of fatigue, joint aches and jaundice, usually after 6 months to many years of therapy. A hepatocellular pattern of enzyme elevations is typical with ALT levels ranging from 3- to 20-fold elevated depending upon the severity and duration of the injury. Autoantibodies are usually present, typically antinuclear antibody (ANA) at titers of >1:160. In some cases, ANA may initially be negative, arising later as the disease progresses or starts to improve. Immunoglobulins are also usually elevated and liver biopsy demonstrates changes typical of autoimmune hepatitis with active interface hepatitis, spotty eosinophilic necrosis and portal infiltrates rich in lymphocytes and plasma cells. Fibrosis is uncommon, but can occur, particularly if the disease is prolonged and minocycline continued in the face of hepatic injury. The condition will resolve spontaneously if minocycline is withdrawn, but corticosteroids are often used. In long term follow up after stopping minocycline, chronic injury is rare, if it occurs at all and generally all symptoms and laboratory test abnormalities resolve within 6 to 12 months of stopping, although patients may continue to have low titers of ANA.

Other immunologically mediated syndromes associated with minocycline use include a serum sickness like syndrome (generally within 3 to 12 weeks of starting), a lupus-like syndrome and hemolytic anemia (the latter two with chronic therapy). Liver injury can accompany these other autoimmune conditions, but is generally anicteric, mild and rapidly reversible. The pattern of serum enzyme elevations is typically hepatocellular and autoantibodies are common.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with minocycline use is probably immunological, mediated by autoimmune reactions against liver cells or minocycline adducts present in the liver. Patients with minocycline induced liver injury have been reported to have an increased frequency of the rare HLA alelle B*35:02, but most cases lack this allele and clinical features are not different in those with or without the HLA association.

### Outcome and Management

The acute liver injury attributed to minocycline is usually self-limited in course, although fatal examples have been reported. In addition, the autoimmune hepatitis like syndrome caused by minocycline can be severe, and fatal outcomes have been described. Most cases, however, resolve slowly with withdrawal of the agent. Corticosteroids are often used to treat minocycline induced liver injury, largely because it resembles spontaneous autoimmune hepatitis and responds rapidly to immunosuppressive therapy. The effectiveness of corticosteroids in speeding or ensuring recovery from minocycline induced autoimmune hepatitis has not been proven, but anecdotal cases suggest a fairly dramatic effect. If corticosteroids are used, the dose should be rapidly reduced and discontinued within 3 to 6 months. Furthermore, patients should be followed carefully after withdrawal of corticosteroids. Recurrence of hepatitis after withdrawal should suggest that the autoimmune hepatitis was unrelated to the minocycline or that the minocycline brought out the autoimmune diathesis that is self-sustaining. Autoimmune hepatitis not caused by medications usually requires long term if not life long immunosuppressive therapy. There is no information about possible cross sensitivity to hepatic injury among the various tetracyclines. Interestingly, doxycycline which resembles minocycline structurally, has been associated with a short latency acute cholestatic or mixed hepatitis with immunoallergic features, but has not been associated definitively with the longer latency autoimmune hepatitis-like syndrome.

Drug Class: Antiinfective Agents, Tetracyclines

## CASE REPORTS

### Case 1. Chronic hepatitis with autoimmune features caused by minocycline.(1)

A 20 year old woman had been taking minocycline for acne for one and a half years when she developed joint pains in the hands, wrists, hips and ankles. She stopped minocycline and began to feel better, but was found to have markedly elevated serum enzymes on routine evaluation of the joint symptoms a few weeks later. She denied significant past medical history and had no risk factors for viral hepatitis. She took no other medications except oral contraceptives and did not drink alcohol regularly. Initially, serum ALT and AST were 15- to 20-fold elevated, but alkaline phosphatase and serum bilirubin were normal. Tests for hepatitis A, B, and C and for infectious mononucleosis were negative. Autoantibody testing showed a positive antinuclear antibody (1:160), but negative tests for smooth muscle and liver-kidney microsomal antibodies. Serum globulins were elevated as was IgG (1960 mg/dL, normal <1520). Ceruloplasmin was low normal. An ultrasound of the abdomen showed normal gallbladder and no enlargement of bile ducts. A liver biopsy showed changes suggestive of autoimmune hepatitis with marked interface hepatitis, portal inflammation with lymphocytes and plasma cells, but no fibrosis. She was started on prednisone and laboratory test abnormalities improved rapidly.

#### Key Points

Medication: | Minocycline (100 mg daily)
Pattern: | Hepatocellular (elevations in ALT only)
Severity: | 1+ (no jaundice)
Latency: | 1.5 years
Recovery: | 8 months on prednisone
Other medications: | Oral contraceptives, rare use of ibuprofen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
1.5 years | 1 month | 607 | 87 | 0.2
| 1.5 months | 965 | 86 | 0.4
2.2 years | 9 months | 216 | 88 | 0.3 | Biopsy
| 10 months | 135 | 90 | 0.4 | Prednisone started
| 11 months | 41 | 55 | 0.3
2.5 years | 12 months | 27 | .. | 0.3
| 15 months | 55 | 57 | .. | Prednisone stopped
3 years | 18 months | 45 | 62 | 0.3
4 years | 30 months | 23 | | Normal
Normal Values | | <35 | <130 | <1.2

#### Comment

The major symptoms were arthralgias, suggesting that the reaction to minocycline therapy was a lupus-like syndrome. These symptoms, however, abated and the patient was found to have a fairly significant anicteric hepatitis which was slow to resolve. Ultimately, a liver biopsy was done that suggested autoimmune hepatitis. Thereupon, prednisone was started with prompt improvement in serum aminotransferase levels. The dose of prednisone was gradually decreased and stopped within 6 months. She had no further symptoms, but serum ALT levels were intermittently abnormal.

### Case 2. Severe acute hepatitis with autoimmune features caused by minocycline.(1)

A 21 year old man was started on minocycline for acne and two months later developed fatigue, dark urine, and weight loss and stopped therapy. A week later, he was admitted to the hospital because of jaundice. He denied a history of liver disease and risk factors for viral hepatitis. He drank alcohol rarely. Serum bilirubin was elevated as were serum aminotransferase levels. Tests for hepatitis A, B, and C and for infectious mononucleosis were negative. Autoantibody testing showed a positive antinuclear antibody (1:1280), but negative tests for smooth muscle and liver-kidney microsomal antibodies. A liver biopsy was done which showed changes suggestive of autoimmune hepatitis with marked activity. He was started on prednisone and rapidly improved. Therapy was gradually reduced and then discontinued several months later, without relapse of symptoms or recurrence of laboratory abnormalities.

#### Key Points

Medication: | Minocycline (100 mg daily for 9 weeks)
Pattern: | Hepatocellular (elevations in ALT only)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 8 weeks
Recovery: | 2 months on prednisone
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
10 weeks | 1 week | 1343 | 783 | 5.7
11 weeks | 2 weeks | 1649 | 638 | 4.8 | Liver biopsy
Prednisone (60 mg daily) started
14 weeks | 5 weeks | 83 | 145 | 1.1
Normal Values | | <35 | <130 | <1.2

#### Comment

Minocycline can cause either an acute or a chronic hepatitis, but both are characterized by a hepatocellular pattern of serum enzyme elevations, the presence of autoantibodies and a liver biopsy showing changes that resemble autoimmune hepatitis. Spontaneous recovery with stopping minocycline is the rule, but recovery can be prolonged, and prednisone therapy may speed the process. Whether prednisone actually improves ultimate outcome has not been proven. Nevertheless, both drug induced and spontaneous autoimmune hepatitis can be severe and even fatal, and prednisone therapy may provide rapid relief. Most important, however, is to limit the dose and duration of therapy, carefully monitoring patients after stopping for evidence of recurrence.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Minocycline – Generic, Dynacin®, Minocin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=minocycline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Minocycline Hydrochloride | 13614-98-7 | C23-H27-N3-O7.Cl-H
Doxycycline Monohydrate | 17086-28-1 | C22-H24-N2-O8.H2-O

## CITED REFERENCES

1 de Boer YS, Kosinski AS, Urban TJ, Zhao Z, Long N, Chalasani N, Kleiner DE, Hoofnagle JH; Drug-Induced Liver Injury Network. Features of autoimmune hepatitis in patients with drug-induced liver injury. Clin Gastroenterol Hepatol 2017; 15: 103-12. 27311619

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2026

Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury).
MacDougall C, Chambers HF. Tetracyclines and glycylcyclines. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1521-6. (Textbook of pharmacology and therapeutics).
Schultz JC, Adamson JS Jr, Workman WW, Norman TD. Fatal liver disease after intravenous administration of tetracycline in high dosage. N Engl J Med 1963; 269: 999-1004. (Initial dramatic report of acute fatty liver due to iv tetracycline; a rapidly fatal multisystem disease appeared in 6 pregnant women in their last trimester or early postpartum period after 3 to 5 days of relatively high doses of iv tetracycline; all developed jaundice [bilirubin 4.9-12.5 mg/dL] with mild AST [72-170 U/L] and Alk P [9-17 King Armstrong U/L] elevations, prolongation of protime, acidosis and renal dysfunction. Autopsy showed foamy hepatocytes, fat by oil red O stain and minimal hepatocyte necrosis). 14059734
Dowling HF, Lepper MH. Hepatic reactions to tetracycline. JAMA 1964; 188: 307-9. (Review of literature on acute fatty liver due to tetracycline and recommendations on its use: avoiding doses >2 g/day and cautious use in women in last trimester of pregnancy). 14114004
Horwitz ST, Marymont JH Jr. Fatal liver disease during pregnancy associated with tetracycline therapy. Report of a case. Obstet Gynecol 1964; 23: 826-9. (After complicated Caesarian and emergency hysterectomy with shock and bleeding, 41 year old woman received tetracycline given iv for 4 days, then orally to day 8; on day 10 she developed fever, acidosis and ileus, dying on day 16 with multiorgan failure and jaundice; autopsy showed fatty liver). 14168241
Norman TD, Schultz JC, Hoke RD. Fatal liver disease following the administration of tetracycline. South Med J 1964; 57: 1038-42. (Further analysis of 6 cases of acute fatty liver after tetracycline in pregnant women with histological changes). 14179316
Whalley PJ, Adams RH, Combes B. Tetracycline toxicity in pregnancy. Liver and pancreatic dysfunction. JAMA 1964; 189: 357-62. (Five cases of acute fatty liver with azotemia and pancreatitis after 4-17 days of iv or oral therapy 1-2 g/day: bilirubin 1.2-18.8 mg/dL; AST 34-780 U/L; Alk P 8.6-22 BU/L; 1 case fatal. The anicteric case had pancreatitis and was attributed to oral drug but had fat on liver biopsy). 14160508
Brewer T. Tetracycline hepatotoxicity. Br Med J 1965; 1: 995. (Letter questioning role of tetracycline in acute fatty liver). 14260641
Finn WF, Horwitz ST. Maternal death due to fatty metamorphosis of liver following tetracycline therapy. N Y State J Med 1965; 65: 662-7. (After Caesarian section, followed by hysterectomy and pneumonia, 41 year old woman received iv tetracycline for 4 days, followed by oral and then iv drug again, developing shock and jaundice; autopsy showed fatty liver without necrosis). 14251580
Ichida F, Watanabe K, Ishiwara S, Inoue K, Tanabe Y. [A case of cholestatic jaundice due to tetracycline-triacetyloleandomycin] Nippon Naika Gakkai Zasshi 1965; 54:142-7. Japanese. PMID: 5294320
Kunelis CT, Peters JL, Edmondson HA. Fatty liver of pregnancy and its relationship to tetracycline therapy. Am J Med 1965; 38: 359-77. (Classical clinical and histologic description of syndrome in 12 pregnant women, ages 19-31, given tetracycline for 3 to 12 days [total dose 1.5 to 14 g] after 16-39 weeks of pregnancy [bilirubin 12-19.8 mg/dL, ALT 24-210 U/L, AST 36-760 U/L, lactic acid high in 3/3 patients], 67% fatal, often accompanied by multiorgan failure, pancreatitis and shock). 14266828
Tapp E, Carroll R. Tetracycline accumulation in toxic liver damage. J Pathol Bacteriol 1965; 89: 715-21. (Animal studies showing accumulation of tetracycline in damaged hepatocytes, particularly with high levels of calcium). 14320315
Winterling AN, Goldman RL. Hepatic and renal lesions in a case of tetracycline toxicity during long-term estrogen therapy after orchiectomy. Calif Med 1965; 102: 314-6. (66 year old man post-orchiectomy for prostate cancer developed sudden onset of fever, lactic acidosis and mild jaundice [bilirubin 2.9 mg/dL] after 8 days of iv tetracycline [17 g], subsequently died after emergency laparotomy; autopsy showed fatty liver). 14291456
Wruble LD, Ladman AJ, Britt LG, Cummins AJ. Hepatotoxicity produced by tetracycline overdosage. JAMA 1965; 192: 6-8. (56 year old woman with cecal volvulus developed jaundice [bilirubin 7.8 mg/dL, AST 98 U/L, Alk P normal] 2 days after receiving 8 g of tetracycline, subsequently progressing to liver failure and death; autopsy showed fatty liver). 14262279
Wruble LD, Cummins AJ. Tetracycline and fatty liver. Am J Dig Dis 1965; 10: 742-4. (Editorial on tetracycline induced acute fatty liver with discussion of mechanisms focusing on mitochondrial injury). 14316764
Tetracyclines and the liver in pregnancy. Lancet 1966; 1: 357-8. (Editorial on the history of acute fatty liver of pregnancy, first described by Sheehan in 1940 and later linked to high dose iv tetracycline in pregnancy, but also in nonpregnant women and in men). 4159865
Davis JS, Kaufman RH. Tetracycline toxicity. A clinicopathologic study with special reference to liver damage and its relationship to pregnancy. Am J Obstet Gynecol 1966; 95: 523-9. (Six cases of acute fatty liver, 1 man and 5 women [4 pregnant] given intravenous tetracycline for 9-10 days [3-6 g] [bilirubin 3-12.5 mg/dL, ALT 34-310 U/L], all acidotic and all died, autopsy showing fatty liver). 5939019
Schiffer MA. Fatty liver associated with administration of tetracycline in pregnant and nonpregnant women. Am J Obstet Gynecol 1966; 96: 326-32. (Six cases of acute fatty liver from tetracycline, 2 in pregnancy at 34- and 40 weeks; 4 in nonpregnant women, but clinical course not described). 5919490
Aach R, Kissane J eds. Clinicopathologic conference. A seventeen-year-old girl with fatty liver of pregnancy following tetracycline therapy. Am J Med 1967; 43: 274-83. (Clinicopathologic conference describing 17 year old pregnant woman who developed suspected pyelonephritis, was treated with im and oral tetracycline and 8 days later developed multiorgan failure, lactic acidosis and died despite induced delivery of a stillborn child). 6034958
Peters RL, Edmondson HA, Mikkelsen WP, Tatter D. Tetracycline-induced fatty liver in nonpregnant patients. A report of six cases. Am J Surg 1967; 113: 622-32. (Classical description of clinical and histologic features of tetracycline induced acute fatty liver in nonpregnant patients; 6 nonpregnant women, ages 18-62, given iv tetracycline for 3-13 days [9-26 g] presenting with jaundice and lethargy; peak AST 52-960 U/L; bilirubin 2.7-7.4 mg/dL, often with complex and critical course, pancreatitis and renal failure, acidosis; fatty liver on autopsy). 6021433
Damjanov I, Arnold R, Faour M. Tetracycline toxicity in a nonpregnant woman. JAMA 1968; 204: 934. (20 year old woman given iv tetracycline for 8 days after second of two gall bladder operations developed sudden onset of renal and hepatic failure [bilirubin 4.2 mg/dL, ALT 620 U/L], autopsy showed fatty liver and acute tubular necrosis). 5694615
Robinson MJ, Rywlin AM. Tetracycline-associated fatty liver in the male. Report of an autopsied case. Am J Dig Dis 1970; 15: 857-62. (72 year old man given 10 days of iv tetracycline [30 g total] developed worsening liver injury followed by hepatic and renal failure and severe acidosis [bilirubin 6.8 mg/dL, AST 1550 KU/L, Alk P 15 KA U/L]; autopsy showed fatty liver, fatty vacuolization of renal tubular cells and pancreatitis). 5459744
Breen KJ, Perkins KW, Mistilis SP, Shearman R. Idiopathic acute fatty liver of pregnancy. Gut 1970; 11: 822-5. (23 year old woman who survived acute fatty liver of pregnancy; onset day after spontaneous labor and stillborn delivery [bilirubin 7.9 mg/dL, Alk P 70 King Armstrong U/L, AST 67 U/L, prothrombin index 50%], liver biopsy showed fatty liver, improved with dextrose administration). 5485832
Combes B, Whalley PJ, Adams RH. Tetracycline and the liver. Prog Liver Dis 1972; 4: 589-96. (Review of hepatotoxicity of tetracycline, including studies of pathogenesis). 4569011
Wenk RE, Gebhardt FC, Bhagavan BS, Lustgarten JA, McCarthy EF. Tetracycline-associated fatty liver of pregnancy, including possible pregnancy risk after chronic dermatologic use of tetracycline. J Reprod Med 1981; 26: 135-41. (Two cases of acute fatty liver over a 15 year period and 60,000 deliveries; one woman received tetracycline for 3 days, the second had no history of its use, but had tetracycline detected in bony tissue suggestive of chronic use). 7230149
Böcker R, Estler CJ, Müller S, Pfandzelter C, Spachmüller B. Comparative evaluation of the effects of tetracycline, rolitetracycline and doxycycline on some blood parameters related to liver function. Arzneimittelforschung 1982; 32: 237-41. (Minocycline caused a dose dependent rise in AST and increase in triglycerides, but no hepatic histological changes in mice; similar findings were previously reported with tetracycline). 7200783
Burette A, Finet C, Prigogine T, De Roy G, Deltenre M. Acute hepatic injury associated with minocycline. Arch Intern Med 1984; 144: 1491-2. (57 year old woman developed jaundice after 4 days of iv minocycline for aspiration pneumonia: [bilirubin ~3.5 mg/dL, ALT 1050 U/L, Alk P 680 U/L, and high amylase], biopsy showed fatty liver with minimal inflammation). 6732411
Schrumpf E, Nordgard K. Unusual cholestatic hepatotoxicity of doxycycline in a young male? Scand J Gastroenterol 1986; 21 (Suppl 120): 68. Not in PubMed (Abstract: Patient developed severe and prolonged cholestatic hepatitis after 2 weeks of oral doxycycline [bilirubin 9.8 rising to 69.5 mg/L, ALT 53 to 132 U/L, Alk P 283 to 775 U/L] and severe itching; ultimate recovery after 6 months).
Davies MG, Kersey PJ. Acute hepatitis and exfoliative dermatitis associated with minocycline. BMJ 1989; 298: 1523-4. (16 year old boy and 17 year old girl developed severe hepatitis after 4 weeks of minocycline, both with severe skin rash [toxic epidermal necrolysis], fever, jaundice, lymphadenopathy and leukemoid reactions; one fatal, but history of travel to Africa and exposure to antimalarials). 2527068
Adams LE, Hess EV. Drug-related lupus. Incidence, mechanisms and clinical implications. Drug Saf 1991; 6: 431-49. (Review of drug related lupus-like syndrome, linked to more than 60 agents including isoniazid, hydralazine, chlorpromazine, methyldopa and procainamide. Usually presents with arthralgias and fever and ANA positivity, usually occurring with long term use of the medication). 1793523
Böcker R, Estler CJ, Ludewig-Sandig D. Evaluation of the hepatotoxic potential of minocycline. Antimicrob Agents Chemother 1991; 35: 1434-6. (High dose studies in rats showed rises in AST and hepatic triglycerides, but no changes in liver histology). 1929305
Lienart F, Morissens M, Jacobs P, Ducobu J. Doxycycline and hepatotoxicity. Acta Clin Belg 1992; 47: 205-8. (42 year old woman with severe cardiomyopathy developed encephalopathy and enzyme elevations with jaundice after 5 days of oral doxycycline [bilirubin 1.2 mg/dL, ALT 139 U/L, Alk P 373 U/L, ammonia 99 mcg/dL], resolving rapidly on stopping; likely due to heart failure and ischemia rather than drug induced liver injury). 1332350
Min DI, Burke PA, Lewis WD, Jenkins RL. Acute hepatic failure associated with oral minocycline: a case report. Pharmacotherapy 1992; 12: 68-71. (39 year old woman developed fatigue and nausea after 4 weeks of minocycline and vitamin A [50,000 U bid] followed by high fever, lymphadenopathy and jaundice progressing to acute liver failure [bilirubin rising from 0.9 to 23.5 mg/dL, ALT 120 to 1625 U/L, Alk P 892 U/L], ultimately resolving spontaneously after stopping). 1532250
Boudreaux JP, Hayes DH, Mizrahi S, Hussey J, Regenstein F, Balart L. Fulminant hepatic failure, hepatorenal syndrome, and necrotizing pancreatitis after minocycline hepatotoxicity. Transplant Proc 1993; 25: 1873. (17 year old girl developed acute liver failure while taking minocycline, but no information given on dose, latency or laboratory abnormalities). 8470208
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119 (7 Pt 1): 576-83. (Case control study using Medicaid billing results between 1980-87 found 107 cases of hospitalization for unexplained hepatitis, odds ratios for erythromycin 5.2; sulfonamides 11.4; tetracyclines 5.2; total of 5 cases exposed to tetracycline, doxycycline or minocycline). 8363168
Hunt CM, Washington K. Tetracycline-induced bile duct paucity and prolonged cholestasis. Gastroenterology 1994; 107: 1844-7. (Two cases of severe and prolonged cholestatic hepatitis and bile duct paucity after oral tetracyclines; 37 year old woman developed jaundice 2 days after 3 day course of doxycycline with prolonged cholestasis [peak bilirubin 30 mg/dL], but ultimate recovery; 63 year old woman developed jaundice 6 weeks after a 2 week course of tetracycline [bilirubin 11.8 mg/dL, ALT 245 U/L], with prolonged jaundice [peak bilirubin 29.5 mg/dL) and persistence of enzyme elevations for >3 years [Alk P 631 U/L, ALT 97 U/L]). 7958700
Kaufmann D, Pichler W, Beer JH. Severe episode of high fever with rash, lymphadenopathy, neutropenia, and eosinophilia after minocycline therapy for acne. Arch Intern Med 1994; 154: 1983-4. (35 year old woman developed fever, rash and eosinophilia 3 weeks after starting minocycline for acne with normal ALT, AST and bilirubin and resolution in ~10 days of stopping, indicating a serum sickness-like syndrome without hepatitis). 8074603
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports between 1978 and 1987 in Denmark; no tetracycline is mentioned as a cause). 1506809
Gordon PM, White MI, Herriot R, Martin JC, Reid DM. Minocycline-associated lupus erythematosus. Brit J Dermatol 1995; 132: 120-1. (15 year old girl developed arthralgias and lupus-like syndrome after 2 years of minocycline therapy of acne; liver tests were normal, ANA 1:640, resolved with stopping). 7756122
Castex F, Canva-Delcambre V, Maunoury V, Talbodec N, Wolchies E, Paris JC. [Acute hepatitis induced by minocycline] Gastroenterol Clin Biol 1995; 19: 640-1. French. PMID: 7590035 (30 year old woman developed jaundice 8 days after starting minocycline [bilirubin 2.0 mg/dL, ALT 23 times ULN, Alk P normal, ANA negative], with resolution of liver test abnormalities within 1 month of stopping).
Gough A, Chapman S, Wagstaff K, Emery P, Elias E. Minocycline induced autoimmune hepatitis and systemic lupus erythematosus-like syndrome. BMJ 1996; 312: 169-72. (Brief report of 4 cases of jaundice developing during long term minocycline therapy and review of 16 cases reported to British Committee on Safety of Medicines; no specific laboratory results provided). 8563540
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; triacetyloleandomycin accounted for 21 cases [2.1%] and minocycline for at least 4). 8816722
Goulden V, Glass D, Cunliffe WJ. Safety of long-term high-dose minocycline in the treatment of acne. Brit J Dermatol 1996; 134: 693-5. (Prospective study of safety of 100-200 mg minocycline given daily for average of 10 months, 200 of 700 patients who had liver tests done, there were “no significant abnormalities”). 8733373
Knowles SR, Shapiro L, Shear NH. Serious adverse reactions induced by minocycline. Report of 13 patients and review of the literature. Arch Dermatol 1996; 132: 934-9. (15 cases with adverse reactions to minocycline; one with Stevens-Johnson syndrome and acute liver failure arising within 29 days of starting minocycline, necessitating liver transplantation). 8712844
Malcolm A, Heap TR, Eckstein RP, Lunzer MR. Minocycline-induced liver injury. Am J Gastroenterol 1996; 91: 1641-3. (Three men and 3 women, ages 15-48, treated with minocycline for 4 weeks to 2 years developed liver injury [peak ALT 257 to 3824 U/L, 3 ANA positive, 3 with jaundice, most had mild eosinophilia], liver biopsy showed chronic hepatitis in 2, all recovered completely, two with corticosteroid therapy). 8759678
Tham SN, Kwok YK, Chan HL. Cross-reactivity in fixed drug eruptions to tetracyclines. Arch Dermatol 1996; 132: 1134-5. (Among 9 Chinese patients with a fixed drug eruption due to tetracycline, all had recurrence on doxycycline and 3 on minocycline; no mention of liver involvement). 8795565
MacNeil M, Haase DA, Tremaine R, Marrie TJ. Fever, lymphadenopathy, eosinophilia, lymphocytosis, hepatitis, and dermatitis: a severe adverse reaction to minocycline. J Am Acad Dermatol 1997; 36 (2 Pt 2): 347-50. (17 year old girl developed fever, lymphadenopathy, severe rash and mild hepatitis 3 weeks after starting minocycline for acne [bilirubin 2.3 mg/dL, ALT 134 U/L, Alk P 309 U/L, ANA negative] required corticosteroid therapy, but ultimately resolved). 9039216
Herzog D, Hajoui O, Russo P, Alvarez F. Study of immune reactivity of minocycline-induced chronic active hepatitis. Dig Dis Sci 1997; 42: 1100-3. (16 year old girl developed arthralgias and anicteric hepatitis after 18 months of therapy with minocycline for acne [bilirubin evidently normal, ALT 392 U/L, Alk P normal, ANA 1:1280], resolved upon stopping; found serum antibodies to 90 kD and 50 kD fractions of HepG2 cells, possibly P-450 proteins). 9149070
Björnsson E, Lindberg J, Olsson R. Liver reactions to oral low-dose tetracyclines. Scand J Gastroenterol 1997; 32: 390-5. Review. PMID: 9140164 (32 year old man developed abdominal pain, dark urine and rash within 24 hours of starting doxycycline which he had received in the past [bilirubin 4.3- 8.1 mg/dL, ALT 3.5 times ULN, Alk P 1.1 times ULN], resolving within 3 months of stopping; thorough review of all published and SADRAC reported cases of oral tetracycline associated liver injury found 15 cases, only 6 rated as likely, none with tetracycline, 5 doxycycline, 1 lymecycline).
Bruguera M, Padrós J. [Acute hepatitis associated with treatment with minocycline] Med Clin (Barc). 1997; 108: 596. (18 year old woman found to have enzyme elevations without symptoms or jaundice 1 month after starting minocycline [bilirubin normal, ALT 283, Alk P normal, ANA negative], resolving within 2-3 months of stopping). 9280793
Crosson J, Stillman MT. Minocycline-related lupus erythematosus with associated liver disease. J Am Acad Dermatol 1997; 36 (5 Pt 2): 867-8. (22 year old woman developed arthralgias 2 years after starting minocycline therapy for acne [bilirubin 0.9 mgdL, ALT 292 U/L, Alk P 64 U/L, ANA 1:80], symptoms resolving rapidly upon stopping, but recurring abruptly after a single tablet, and serum ALT remained elevated for another 2 months before resolving). 9146570
Golstein PE, Deviere J, Cremer M. Acute hepatitis and drug-related lupus induced by minocycline treatment. Am J Gastroenterol 1997; 92: 143-6. (19 year old man developed fatigue, weight loss, arthralgias and liver test abnormalities after 20 months of therapy with minocycline for acne [bilirubin normal, ALT 374 U/L, Alk P normal, ANA 1:640, IgG 2280 mg/dL], resolving upon stopping, but ANA persisted in high titer [1:1280 9 months later]). 8995955
Hoefnagel JJ, van Leeuwen RL, Mattie H, Bastiaens MT. [Side effects of minocycline in the treatment of acne vulgaris] Ned Tijdschr Geneeskd 1997; 141: 1424-7. Dutch. PMID: 9542866 (Editorial on association of minocycline with lupus, autoimmune hepatitis, vasculitis and serum sickness-like syndromes).
Shapiro LE, Knowles SR, Shear NH. Comparative safety of tetracycline, minocycline, and doxycycline. Arch Dermatol 1997; 133: 1224-30. (Review of toxicity of tetracyclines from literature and a Canadian database; minocycline had the highest rates of adverse events, but all were relatively safe: no lupus-like syndrome associated with doxycycline or tetracycline). 9382560
Angulo JM, Sigal LH, Espinoza LR. Coexistent minocycline-induced systemic lupus erythematosus and autoimmune hepatitis. Semin Arthritis Rheum 1998; 28: 187-92. (22 year old woman with arthralgias and jaundice after 1 year of minocycline therapy for acne [bilirubin 3.2 mg/dL, ALT 916 U/L, Alk P 204 U/L, ANA 1:640], resolving upon stopping, but arthralgias required prednisone for 18 months). 9872479
Bhat G, Jordan J Jr, Sokalski S, Bajaj V, Marshall R, Berkelhammer C. Minocycline-induced hepatitis with autoimmune features and neutropenia. J Clin Gastroenterol 1998; 27: 74-5. (18 year old man developed hepatitis after 2 years of intermittent therapy with minocycline [bilirubin 4.8 mg/dL, ALT 1270 U/L, Alk P 117 U/L, ANA 1:1280], rapid response to prednisone and no relapse when stopped). 9706776
Matteson EL, Johnson BW, Maher JD. Arthralgias, myalgias, and autoimmune hepatitis with minocycline therapy. J Rheumatol 1998; 25: 1653-4. (20 year old man developed fever and arthralgias after taking minocycline for 5 years for acne [no mention of bilirubin or jaundice, ALT 307 U/L, ANA 1:5280], full recovery 4 weeks after stopping). 9712119
Pavese P, Sarrot-Reynauld F, Bonadona A, Massot C. [Immunoallergic reaction with hepatitis induced by minocycline] Ann Med Interne (Paris) 1998; 149: 521-3. French. PMID: 10021906 (19 year old woman developed lupus-like syndrome and hepatitis after 2 years of minocycline therapy, resolving within 2 months of stopping).
Teitelbaum JE, Perez-Atayde AR, Cohen M, Bousvaros A, Jonas MM. Minocycline-related autoimmune hepatitis: case series and literature review. Arch Pediatr Adolesc Med 1998; 152: 1132-6. (Three case reports of chronic autoimmune-like hepatitis in 15-16 year olds, arising 1-1.5 years after starting minocycline for acne [bilirubin normal to 26 mg/dL, ALT 363, 988 and 904 U/L, Alk P normal, all with ANA and high IgG], resolving in 2 to 9 months, 2 treated with prednisone; literature review). 9811293
Angulo JM, Sigal LH, Espinoza LR. Minocycline induced lupus and autoimmune hepatitis. J Rheumatol 1999; 26: 1420-1. (22 year old woman had sudden onset of arthralgias and then jaundice after a year of minocycline for acne [bilirubin 3.2 mg/dL, ALT 916 U/L, Alk P 204 U/L, ANA 1:2560], biopsy showing chronic hepatitis, resolving rapidly upon stopping, but arthralgias required long term prednisone). 10381074
Dadamessi I, Leduc I, Duché A, et al. [Autoimmune hepatitis and lupus syndrome associated with minocycline] Rev Med Interne 1999; 20: 930-3. French. PMID: 10573731 (25 year old woman had two episodes of ALT elevations [peak 266 and 256 U/L, ANA 1:140 and 1:320] arising during minocycline therapy [first asymptomatic, second with arthralgias], resolving each time with discontinuation).
Elkayam O, Yaron M, Caspi D. Minocycline-induced autoimmune syndromes: an overview. Semin Arthritis Rheum 1999; 28: 392-7. (Systematic review of literature on autoimmune syndromes from minocycline, 4 patterns: serum sickness, lupus-like syndrome, autoimmune hepatitis and vasculitis; usually presenting after 1-20 years, ANA common but so is pANCA, features may overlap, hepatitis most common: 66 cases reported). 10406406
Westermann GW, Böhm M, Bonsmann G, Rahn KH, Kisters K. Chronic intoxication by doxycycline use for more than 12 years. J Intern Med 1999; 246: 591-2. (38 year old man took large doses of doxycycline chronically and developed repeated bouts of mild jaundice [bilirubin 3.4-5.0 mg/dL, ALT 44-118 U/L, Alk P 466 U/L] and weakness, skin discoloration and heart block, resolving upon stopping). 10620103
Sturkenboom MC, Meier CR, Jick H, Stricker BH. Minocycline and lupuslike syndrome in acne patients. Arch Intern Med 1999; 159: 493-7. (Case control study in 27,688 acne patients in UK database, risk of lupus increased 8.5 fold in minocycline treated patients, not with other tetracyclines, typically long term therapy; liver involvement not mentioned; more common in women, absolute risk low). 10074958
Colmegna I, Perandones CE, Chaves JG. Minocycline induced lupus and autoimmune hepatitis. J Rheumatol 2000; 27: 1567-8. (22 year old woman developed fever and polyarthralgias after 40 days of 9th course of minocycline for acne [bilirubin 4.9 mg/dL, ALT 1300 U/L and ESR 100], resolving rapidly but with prolonged rheumatological complaints requiring prednisone long term: ANA negative). 10852297
Goldstein NS, Bayati N, Silverman AL, Gordon SC. Minocycline as a cause of drug-induced autoimmune hepatitis. Report of four cases and comparison with autoimmune hepatitis. Am J Clin Pathol 2000; 114: 591-8. (Four cases of minocycline hepatitis and comparison to 10 spontaneous autoimmune hepatitis cases showed no distinguishing features except resolution with stopping drug; 16-52 year old women developed liver injury 4 months to 12 years after starting minocycline [bilirubin 0.4, 1.2, 6.5 and 7.3 mg/dL, ALT 137, 343, 700, and 1288 U/L, Alk P 49, 83, 138 and 253 U/L, all ANA positive], histology showed fibrosis in 2, all responded to prednisone with resolution persisting after stopping corticosteroids). 11026106
Lawrenson RA, Seaman HE, Sundström A, Williams TJ, Farmer RD. Liver damage associated with minocycline use in acne: a systematic review of the published literature and pharmacovigilance data. Drug Saf 2000; 23: 333-49. (Systematic review of cases of liver injury from minocycline in patients with acne defining two patterns – acute and chronic with different latencies, associated findings and potential outcomes). 11051220
Pohle T, Menzel J, Domschke W. Minocycline and fulminant hepatic failure necessitating liver transplantation. Am J Gastroenterol 2000; 95: 560-1. (20 year old woman given minocycline for 3 years for acne developed autoimmune hepatitis but did not stop minocycline and progressed to hepatic failure and need for transplant 2 months later [bilirubin 11.7 rising to 25.4 mg/dL, ALT 199 U/L, GGT 34 U/L, ANA positive, IgG 2220 mg/dL]). 10685779
Tomer G, Shneider BL. Minocycline-induced hepatitis. J Pediatr Gastroenterol Nutr 2000; 30: 105-6. (Editorial on minocycline and liver injury in children). 10630451
Bachmeyer C, Cadranel JF. Minocycline-induced lupus and autoimmune hepatitis: family autoimmune disorders as possible risk factors. Dermatology 2002; 205: 185-6. (15 year old girl treated for 3 years with minocycline for acne developed polyarthritis, but no jaundice [bilirubin normal, ALT 4 times ULN, Alk P normal, anti-DNA positive, ANA 1:1280], resolving slowly upon stopping with all tests normal at 6 months, except ANA which was still 1:320 12 months later). 12218241
Abe M, Furukawa S, Takayama S, Michitaka K, Minami H, Yamamoto, Horiike N, et al. Drug-induced hepatitis with autoimmune features during minocycline therapy. Intern Med 2003; 42: 48-52. (25 year old Japanese woman developed jaundice after 1 year of minocycline therapy for acne [bilirubin 23.7 mg/dL, ALT 2074 U/L, Alk P 138 U/L, IgG 2110 mg/dL, ANA 1:160], resolving with 3 month course of prednisone, no relapse with stopping). 12583618
Real Martínez Y, Medina S. [Acute hepatitis and minocycline] Rev Esp Enferm Dig 2003; 95: 741-2. Spanish. PMID: 14588070 (14 year old boy developed jaundice after 5 months of minocycline therapy for acne [bilirubin 5.1 mg/dL, ALT 2376 U/L, GGT 83 U/L, IgG 1734 mg/dL, ANA negative, SMA 1:320], treated with corticosteroids for 5 months and no relapse when stopped).
Selimoglu MA, Ertekin V. Autoimmune hepatitis triggered by Brucella infection or doxycycline or both. Int J Clin Pract 2003; 57: 639-41. (11 year old girl was found to have abnormal liver tests 3 weeks after finishing a 6 week course of doxycycline for acute brucellosis [bilirubin 1.2 mg/dL, ALT 222 U/L, Alk P 561 U/L, ANA negative, HLA B8 DRB1*03], a liver biopsy showing inflammation, necrosis and bridging fibrosis, improving on prednisone therapy, relapsing on stopping and ultimately requiring long term azathioprine therapy). 14529072
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none of which were attributed to minocycline, doxycycline or tetracycline). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, one case was attributed to doxycycline, but no other tetracycline mentioned). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease; no tetracycline was listed among the top 20 agents implicated [at least 5 cases]). 16083708
Smith K, Leyden JJ. Safety of doxycycline and minocycline: a systematic review. Clin Ther 2005; 27: 1329-42. (Systematic review of overall safety of doxycycline and minocycline stressing overall low rate of adverse events [13-72 per million prescriptions]; little mention of liver toxicity). 16291409
Galan MV, Potts JA, Silverman AL, Gordon SC. The burden of acute nonfulminant drug-induced hepatitis in a United States tertiary referral center. J Clin Gastroenterol 2005; 39: 64-7. (Ten year experience of 96 patients with acute liver injury, 64 were due to viral hepatitis and 32 to drugs; minocycline accounted for 4 cases and ranked second in frequency [7 from amiodarone and 4 from amoxicillin/clavulanate]). 15599214
Chamberlain MC, Schwarzenberg SJ, Akin EU, Kurth MH. Minocycline-induced autoimmune hepatitis with subsequent cirrhosis. J Pediatr Gastroenterol Nutr 2006; 42: 232-5. (15 year old boy developed signs of cirrhosis after 1 year of minocycline therapy [bilirubin 2.5 mg/dL, ALT 67-83 U/L, Alk P normal, ANA 1:40, anti-DNA positive], treated with 6-mercaptopurine and prednisone with only partial response and found to have cirrhosis on follow up liver biopsy). 16456421
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; the list of most 21 most commonly implicated drugs did not include a tetracycline). 16054882
Basude D, Dhawan A. Re: Minocycline-induced autoimmune hepatitis with subsequent cirrhosis. J Pediatr Gastroenterol Nutr 2007; 44: 389; author reply 389-90. (Letter in response to Chamberlain [2006] arguing that the child likely had a preexisting cryptogenic cirrhosis not related to minocycline therapy). 17325565
Margolis DJ, Hoffstad O, Bilker W. Association or lack of association between tetracycline class antibiotics used for acne vulgaris and lupus erythematosus. Br J Dermatol 2007; 157: 540-6. (Analysis of UK database on 97,694 subjects with acne, 25% received minocycline, 16% doxycycline and 45% other tetracyclines. Hazard ratio for lupus-like syndrome was 3.11 for minocycline; no increased risk or association with doxycycline or other tetracyclines). 17596147
Egiguren L, Minondo L, Zapata E, Castiella A. [Patient with autoimmune hepatitis and idiopathic thrombocytopenic purpura after minocycline therapy] Gastroenterol Hepatol 2007; 30: 565-6. Spanish. PMID: 17980139 (15 year old girl developed jaundice 1 month after starting minocycline therapy for acne [bilirubin 4.4 mg/dL, ALT 1232 U/L, Alk P 555 U/L, ANA 1:1280], developing idiopathic thrombocytopenic purpura when treated with prednisone; no follow up available).
Losanoff JE, Holder-Murray JM, Ahmed EB, Cochrane AB, Testa G, Millis JM. Minocycline toxicity requiring liver transplant. Dig Dis Sci 2007; 52: 3242-4. (33 year old woman developed jaundice 7 weeks after starting minocycline for acne [bilirubin 9.9 mg/dL, ALT 882 U/L, Alk P 191 U/L, ANA positivity], with subsequent worsening despite stopping drug, ultimately requiring liver transplantation; graft showed massive necrosis). 17404879
Heaton PC, Fenwick SR, Brewer DE. Association between tetracycline or doxycycline and hepatotoxicity: a population based case-control study. J Clin Pharm Ther 2007; 32: 483-7. (Analysis of 2 years of Medicaid claims in California found 3377 cases of “hepatotoxicity”; 20 had received tetracycline <45 days before onset; only 4 controls had: adjusted odds ratio 3.7; not elevated for doxycycline; this despite safety record of oral tetracyclines and known hepatotoxicity of doxycycline). 17875115
Ford TJ, Dillon JF. Minocycline hepatitis. Eur J Gastroenterol Hepatol 2008; 20: 796-9. (20 year old developed fatigue and jaundice 1 year after starting minocycline for acne [bilirubin 5.0 mg/dL, AST 1095 U/L, Alk P 178 U/L, ANA 1: 2560], resolving within 1-2 months of stopping accompanied by fall in ANA titers to normal). 18617786
Meropol SB, Chan KA, Chen Z, Finkelstein JA, Hennessy S, Lautenbach E, Platt R, et al. Adverse events associated with prolonged antibiotic use. Pharmacoepidemiol Drug Saf 2008 17: 423-32. (Analysis of 3 large UK and US databases on medication use and clinical outcomes covering ~6 million patients for adverse events related to >1 month of either amoxicillin [0-1.2/100,000], ciprofloxacin [0-5.7/100,000] and doxycycline [0-0.9/100,000 person days], but no mention of liver toxicities). 18383065
Carrascosa MF, Lucena MI, Andrade RJ, Caviedes JRS, et al. Fatal acute hepatitis after sequential treatment with levofloxacin, doxycycline, and naproxen in a patient presenting with acute Mycoplasma pneumoniae infection. Clin Ther 2009; 31: 1014-19. (63 year old man developed acute liver injury 1 week after starting a 3 day course of levofloxacin and 5 days after starting doxycycline [bilirubin 4.0 rising to >35 mg/dL, ALT 1577 U/L, Alk P 189 U/L], with subsequent progressive liver failure and death; biopsy showed massive necrosis). 19539102
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, minocycline accounted for 3 cases, doxycycline for 3 cases and tetracycline was listed as a secondary possible cause for one). 18955056
Chavant F, Lafay-Chebassier C, Beauchant M, Perault-Pochat MC. [Doxycycline induced hepatitis]. Gastroenterol Clin Biol 2008; 32: 825-7. French. PMID: 18823729 (37 year old man developed fatigue 6 weeks after starting doxycycline [bilirubin 2.8 mg/dL, ALT 2322 U/L, Alk P 184 U/L, ANA 1:100], resolving within 6 weeks of stopping).
Robles DT, Leonard JL, Compton N, Waghmare A, McDonough KA, George E, Wolgamot G, Fleckman P. Severe drug hypersensitivity reaction in a young woman treated with doxycycline. Dermatology 2008; 217: 23-6. (20 year old woman developed severe rash and fever 3 weeks after starting doxycycline for acne [bilirubin 2.5 mg/dL, ALT 133 U/L, Alk P 205 U/L, eosinophils 980/µL], requiring intubation and corticosteroid therapy and 3 week hospitalization, ultimately resolving). 18332631
Maubec E, Wolkenstein P, Loriot MA, Wechsler J, Mulot C, Beaune P, Revuz J, Roujeau JC. Minocycline-induced DRESS: evidence for accumulation of the culprit drug. Dermatology 2008; 216: 200-4. (Review of 9 patients with DRESS syndrome due to minocycline; 8 women and 1 man, ages 15-45, onset after 16 to 60 days, 8 with liver “dysfunction”, resolving after 1 to 8 months, but two died, not of liver disease). 18182810
Ramakrishna J, Johnson AR, Banner BF. Long-term minocycline use for acne in healthy adolescents can cause severe autoimmune hepatitis. J Clin Gastroenterol 2009; 43: 787-90. (Three cases of minocycline hepatotoxicity; 16 year olds with onset of jaundice 2, 13 and 24 months after starting minocycline for acne [bilirubin 19.6, 9.1 and 9.5 mg/dL, ALT 1282, 2306 and 2056 U/L, ANA 1:160-1:640], liver biopsies showing hepatitis and fibrosis; all treated with corticosteroids, 2 requiring prolonged therapy). 19262406
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 117 cases attributed to minocycline, but no other tetracycline listed in the top 40 causes). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were due to tetracyclines). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide, and 1 to dapsone). 20949552
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, Lindor K. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. (Among 261 cases of autoimmune hepatitis seen at the Mayo Clinic between 1997 and 2007, 24 were attributed to drugs, 11 to minocycline, 11 to nitrofurantoin and 2 to others; all responded to corticosteroid therapy and all who were withdrawn did not relapse). 20512992
Casella G, Villanacci V, Di Bella C, Drera E, Baldini V, Bassotti G. Acute hepatitis caused by minocycline. Rev Esp Enferm Dig 2010; 102: 668. (80 year old woman was found to have enzyme elevations after a year of minocycline therapy [bilirubin 2.2 mg/dL, ALT 721 U/L, GGT 107 U/L, ANA 1:320, INR 1.2], responding to corticosteroid therapy, and enzymes remained normal after their discontinuation). 21142391
Mailhol C, Tremeau-Martinage C, Paul C, Godel A, Lamant L, Giordano-Labadie F. [Severe drug hypersensitivity reaction (DRESS syndrome) to doxycycline]. Ann Dermatol Venereol 2010; 137: 40-3. French. PMID: 20110067 (59 year old woman developed fever, rash and facial edema 3 weeks after starting doxycycline for malaria prophylaxis [bilirubin normal, ALT 278 U/L, eosinophils 15%, atypical lymphocytosis], resolving on discontinuation).
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: Pathomechanisms and clinical. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics; mentions that hepatotoxicity from oral tetracycline is rare ~1.5 cases per million prescriptions, whereas minocycline has been associated with either an immediate reaction with eosinophilia, dermatitis and enzyme elevations or a delayed autoimmune hepatitis-like syndrome). 20107858
Glenn C, Feldman SR. Letter: Tetracycline-induced hepatotoxicity. Dermatol Online J 2011; 17: 14. (49 year old woman developed fatigue, edema, low albumin and raised alkaline phosphatase levels [bilirubin and ALT normal] 6 months after starting oral tetracycline for rosacea, albumin and alkaline phosphatase levels returning to normal upon stopping, later tolerating doxycycline). 22233750
Czaja AJ. Drug-induced autoimmune-like hepatitis. Dig Dis Sci 2011; 56: 958-76. (Review of drug induced autoimmune hepatitis-like syndromes, most commonly caused by nitrofurantoin and minocycline, but also with hydralazine, methyldopa and more rarely with statins, fibrates, NSAIDs, various herbals and tumor necrosis factor antagonists). 21327704
Aldenhoven M, van Enk JG, Avis WA. [Minocycline-induced autoimmune hepatitis]. Ned Tijdschr Geneeskd 2013; 157: A5465. Dutch. PMID: 23328022 (Abstract: 14 year old girl developed liver injury with positive ANA after long term use of minocycline, resolving after stopping the drug without corticosteroid therapy).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 2 were attributed to doxycycline but none to minocycline). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 37 of which were attributed to an antibiotic, but none to a tetracycline). 24552865
deLemos AS, Foureau DM, Jacobs C, Ahrens W, Russo MW, Bonkovsky HL. Drug-induced liver injury with autoimmune features. Semin Liver Dis 2014; 34: 194-204. (Review of drug induced autoimmune hepatitis with examples due to methyldopa, hydralazine, minocycline and nitrofurantoin). 24879983
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 inpatients with hepatitis of unknown cause enrolled in a prospective case-cohort surveillance study between 2002 and 2011, one was attributed to doxycycline, but no other tetracycline was implicated). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 28 [3%] to minocycline and 4 [0.4%] to doxycycline). 25754159
Urban TJ, Nicoletti P, Chalasani N, Serrano J, Stolz A, Daly AK, Aithal GP, et al; Drug-Induced Liver Injury Network (DILIN); Pharmacogenetics of Drug-Induced Liver Injury group (DILIGEN); International Serious Adverse Events Consortium (iSAEC). Minocycline hepatotoxicity: clinical characterization and identification of HLA-B*35:02 as a risk factor. J Hepatol 2017; 67: 137-44. (The uncommon HLA allele B*35:02 was found in 4 of 25 [16%] of patients with minocycline hepatotoxicity vs 0.6% in a population control group; those with and without this allele did not different in clinical features or outcome). 28323125
de Boer YS, Kosinski AS, Urban TJ, Zhao Z, Long N, Chalasani N, Kleiner DE, Hoofnagle JH; Drug-Induced Liver Injury Network. Features of autoimmune hepatitis in patients with drug-induced liver injury. Clin Gastroenterol Hepatol 2017; 15: 103-12. (Among 88 cases of drug induced liver injury, autoimmune features were found in 83% of nitrofurantoin, 74% of minocycline, 60% of methyldopa and 43% of hydralazine associated cases. ANA and SMA titers and IgG levels tended to fall with recovery, and cases with autoimmune features were similar clinically to those without except for a tendency for a longer latency to onset in those with autoantibodies). 27311619
Harmon EG, McConnie R, Kesavan A. Minocycline-induced autoimmune hepatitis: a rare but important cause of drug-induced autoimmune hepatitis. Pediatr Gastroenterol Hepatol Nutr 2018; 21: 347-50. (17 year old male developed jaundice 5 months after starting minocycline [100 mg daily] for acne [bilirubin 10.2 rising to 21.8 mg/dL, ALT 2229 U/L, Alk P not given, ANA negative], biopsy showing autoimmune-like features leading to a 12 week course of prednisone and ultimate recovery). 30345250
Shankar S, Oliver MR. Primum non nocere: minocycline-induced liver injury in a teenager. J Paediatr Child Health 2018; 54: 1031-3. (15 year old girl developed fever, rash, lymphadenopathy and abdominal pain 4 weeks after starting minocycline [100 mg daily] for acne [bilirubin normal, ALT 688 U/L, GGT 281 U/L, eosinophils 500/μL], treated with corticosteroids and had fully recovered when seen 6 months later). 29962030
Shah J, Shahidullah A, Liu Y. Drug-induced autoimmune hepatitis in a patient treated with minocycline: a rare adverse effect. Case Rep Gastroenterol 2018; 12: 447-52. (31 year old woman developed nausea and abdominal pain 3 months after starting minocycline for acne [bilirubin 1.8 mg/dL, ALT 1138 U/L, Alk P 160 U/L, INR 1.9, ANA 1:160, IgG 3176 mg/dL], with a rapid response to prednisolone [given for 4 weeks] and ultimate complete recovery). PMID: 30186098
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. (Analysis of the spontaneous reports of drug-induced liver injury to the FDA adverse event reporting system [FAERS] made between 2004 and 2020 identified 1435 cases, most due to minocycline [n=547], doxycycline [545], and tigecycline [288] with increasing numbers in recent years). 35364753
Nikolajevic N, Nikolajevic M, Pantic I, Korica B, Kotseva M, Alempijevic T, Jevtic D, et al. Drug-induced liver injury due to doxycycline: a case report and review of literature. Cureus. 2024;16:e59687. (28 year old man with Lyme disease developed nausea 5 days after starting doxycycline [100 mg twice daily] with bilirubin 0.7 mg/dL, ALT 758 U/L, Alk P normal, INR 1.1 and improvement on stopping doxycycline and switching to amoxicillin, with normal liver tests one month later). 38836151
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including doxycycline at an estimate rate of 1 per 3,700 persons per year of exposure; no cases due to minocycline found). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database 4 [1%} were attributed to minocycline, but only one [0.2%] to doxycycline). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 44 cases [3.4%] attributed to minocycline being the 6th most commonly implicated drug and occurring at an estimated rate of 1 per 1,100 persons treated).
Weber S, Gerbes AL. Relapse and need for extended immunosuppression: novel features of drug-induced autoimmune hepatitis. Digestion. 2023;104(3):243-248. (Comparison of patients with autoimmune hepatitis [n=19], to autoimmune-like drug induced liver injury [n=11, 1 due to minocycline] found differences only in the need for long-term immunosuppression [27% vs 13%]). 36603570
García-Cortés M, Ortega-Alonso A, Matilla-Cabello G, Medina-Cáliz I, Castiella A, Conde I, Bonilla-Toyos E, et al. Clinical presentation, causative drugs and outcome of patients with autoimmune features in two prospective DILI registries. Liver Int. 2023;43:1749-1760. (Among 1426 patients with enrolled in the Spanish and Latin American Drug Induced Liver Injury Registries, 33 had autoimmune-like liver injury, which were 58% females, 84% hepatocellular, typically with a long latency, 91% with ANA, 34% SMA, 12% severe and 3% fatal; 8 due to statins, 5 nitrofurantoin, 4 minocycline, only 1 an herbal product). 37269163
Bessone F, Bjornsson ES. Autoimmune-like hepatitis induced by drugs: still many unanswered questions. World J Hepatol. 2025;17:110946. (Review of autoimmune-like drug induced liver injury and features that distinguish it from spontaneous, idiopathic autoimmune hepatitis, the major features being lack or minimal fibrosis and lack of relapse after resolution with or without corticosteroid therapy in drug-induced liver injury with autoimmune features that is common with chronic minocycline therapy in which relapse after corticosteroid-induced remission is very rare, but has been reported). 41368109
Reinhart JM. Drug-induced liver injury. Vet Clin North Am Small Anim Pract. 2025;55:717-730. (Extensive review of drug-induced liver injury in veterinary animals mentions that 39% of dogs and 19% of cats develop ALT elevations on doxycycline therapy but that clinically apparent injury must be rare). 40280782

## OTHER REFERENCE LINKS

1. Recent References on Minocycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=minocycline/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Minocycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=minocycline)